# Entecavir

## OVERVIEW

### Introduction

Entecavir is a guanosine nucleoside analogue used in the treatment of chronic hepatitis B virus (HBV) infection. Entecavir therapy can be associated with flares of the underlying hepatitis B during or after therapy, but has not been linked to cases of clinically apparent liver injury.

### Background

Entecavir (en tek' a vir) is a guanosine analogue with potent activity against HBV and minimal activity against HIV. Entecavir is phosphorylated intracellularly where it acts by competing with guanosine for uptake by the HBV DNA polymerase and incorporation into the growing HBV DNA molecule, leading to inhibition of polymerase activity and chain termination. Entecavir lowers HBV DNA levels and leads to improvements in serum aminotransferase levels in the majority of patients. Long term therapy is well tolerated and antiviral resistance to entecavir is rare. Entecavir was approved by the FDA in 2005 and is currently widely used. Entecavir is indicated for the treatment of chronic hepatitis B and is available in 0.5 and 1 mg tablets under the brand name of Baraclude. An oral solution of 0.05 mg/mL is also available. The recommended dose of entecavir is 0.5 mg orally once daily in adults (and children over the age of 16) with typical chronic hepatitis B and 1.0 mg once daily for patients with lamivudine-resistant HBV infection. Entecavir has slight antiviral activity against HIV which predisposes to antiviral resistance and should not be used alone in patients with HBV-HIV co-infection. Side effects from entecavir are infrequent.

### Hepatotoxicity

Elevations in serum ALT levels occur in 2% to 10% patients with chronic hepatitis B treated with entecavir. These elevations appear to be due to a transient flare in the underlying chronic hepatitis B and occur both during and after therapy. On treatment, ALT flares typically occur during the first 1 to 2 months of therapy and are mild, asymptomatic and self-limited, accompanying the rapid declines in HBV DNA levels. Withdrawal flares in ALT levels occur in 8% to 12% of patients who receive entecavir therapy of hepatitis B and are subsequently withdrawn from treatment. The withdrawal flares arise within 1 to 3 months of stopping treatment and are usually preceded by marked and sudden rises in HBV DNA levels towards pretreatment values. Withdrawal flares of hepatitis B can be symptomatic and severe, and several instances of acute liver failure have been described in patients withdrawn from therapy after 1 to 3 years of treatment. There have been few reports of withdrawal flares after stopping entecavir, because the majority of patients have continued therapy indefinitely. However, the rate of flares and their severity are likely to be similar after stopping entecavir as after withdrawal of other therapies of hepatitis B.

Several instances of lactic acidosis have been reported in patients with advanced hepatitis B who were treated with entecavir; however, lactate levels were reported to be normal in patients with cirrhosis started on entecavir and followed prospectively, and in large clinical trials lactic acidosis has not been reported. The cases of lactic acidosis attributed to entecavir occurred largely in patients with severe, advanced disease and may have been due to septicemia, hypotension and/or hepatic failure rather than an adverse reaction to entecavir. Therapy with entecavir has not been associated with development of the typical syndrome of lactic acidosis, hepatic steatosis and liver failure in patients without severe preexisting liver disease that has been described with stavudine, didanosine and zidovudine treatment. Thus, clinically apparent direct hepatotoxicity from entecavir must be rare, if it occurs at all.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver rinjury).

### Mechanism of Injury

The apparent lack of significant hepatotoxicity from entecavir may be due to its lack of hepatic metabolism. In vitro studies have shown that it does not inhibit mitochondrial function or DNA polymerase gamma.

### Outcome and Management

The ALT elevations associated with initiation of entecavir use are typically asymptomatic and transient and do not warrant dose modification or discontinuation. Patients who are withdrawn from entecavir therapy should be followed carefully for evidence of a withdrawal flare and therapy reinstituted rapidly if any signs of severe liver injury arise.

Agents used in therapy of HBV infection include adefovir, emtricitabine, entecavir, lamivudine, telbivudine, tenofovir, interferon alfa and peginterferon.

Drug Class: Antiviral Agents, Antiretroviral Agents, Hepatitis B Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Adefovir, Didanosine, Emtricitabine, Lamivudine, Stavudine, Telbivudine, Tenofovir, Zidovudine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Entecavir – Baraclude®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=entecavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Entecavir | 142217-69-4 | C12-H15-N5-O3 | Entecavir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2018

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-518. (Review of hepatotoxicity of antiviral agents including agents for hepatitis B).
Acosta EP, Flexner C. Antiviral agents (nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1593-1622. (Textbook of pharmacology and therapeutics).
Sherman M, Yurdaydin C, Sollano J, Silva M, Liaw YF, Cianciara J, Boron-Kaczmarska A, et al.; AI463026 BEHoLD Study Group. Entecavir for treatment of lamivudine-refractory, HBeAg-positive chronic hepatitis B. Gastroenterology 2006; 130: 2039-49. (Trial comparing entecavir [n=141] to lamivudine [n=145] for lamivudine resistant chronic hepatitis B; ALT flares [>10 times normal] occurred in <1% of entecavir [initial on treatment flare] vs 11% of lamivudine-recipients). 16762627
Chang TT, Gish RG, de Man R, Gadano A, Sollano J, Chao YC, Lok AS, et al.; BEHoLD AI463022 Study Group. A comparison of entecavir and lamivudine for HBeAg-positive chronic hepatitis B. N Engl J Med 2006; 354: 1001-10. (Controlled trial comparing entecavir [n=354] to lamivudine [n=355] in patients with HBeAg-positive chronic hepatitis B; on-treatment ALT elevations >5 times ULN occurred in 10% of entecavir- vs 17% of lamivudine-treated subjects [entecavir therapy stopped in one patient]; posttreatment elevations in 2% vs 12%). 16525137
Lai CL, Shouval D, Lok AS, Chang TT, Cheinquer H, Goodman Z, DeHertogh D, et al.; BEHoLD AI463027 Study Group. Entecavir versus lamivudine for patients with HBeAg-negative chronic hepatitis B. N Engl J Med 2006; 354: 1011-20. (Controlled trial comparing entecavir [n=325] to lamivudine [n=313] in patients with HBeAg-negative chronic hepatitis B; on-treatment ALT elevations >5 times normal occurred in 2% of entecavir- vs 3% of lamivudine-treated; posttreatment elevations in 12% vs 29%, no deaths from flares). 16525138
Mazzucco CE, Hamatake RK, Colonno RJ, Tenney DJ. Entecavir for treatment of hepatitis B virus displays no in vitro mitochondrial toxicity or DNA polymerase gamma inhibition. Antimicrob Agents Chemother 2008; 52: 598-605. (In vitro assay for mitochondrial toxicity found no evidence of toxicity of entecavir at 100-fold the typical maximum concentration; zalcitabine [ddC] had marked inhibitory activity). 18056280
Schiff E, Simsek H, Lee WM, Chao YC, Sette H Jr, Janssen HL, Han SH, et al. Efficacy and safety of entecavir in patients with chronic hepatitis B and advanced hepatic fibrosis or cirrhosis. Am J Gastroenterol 2008; 103: 2776-83. (Analysis of 245 patients with advanced chronic hepatitis B in 3 clinical trials; on-treatment flares [ALT >10 times normal] occurred in 1 of 120 entecavir- vs 4 of 125 lamivudine treated patients). 18721244
Sherman M, Yurdaydin C, Simsek H, Silva M, Liaw YF, Rustgi VK, Sette H, et al.; AI463026 Benefits of Entecavir for Hepatitis B Liver Disease(BEHoLD) Study Group. Entecavir therapy for lamivudine-refractory chronic hepatitis B: improved virologic, biochemical, and serology outcomes through 96 weeks. Hepatology 2008; 48: 99-108. (Trial comparing entecavir [n=141] to lamivudine [n=145] for lamivudine resistant chronic hepatitis B; as published previously, ALT flares [>10 times normal] occurred in <1% of entecavir [initial on treatment flare] vs 11% of lamivudine recipients. On stopping therapy, 6 of 54 [11%] entecavir treated subjects had a withdrawal flare, but no follow up given). 18537189
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antiviral agents, but none to drugs used in therapy of hepatitis B). 18955056
Sulkowski MS. Management of hepatic complications in HIV-infected persons. J Infect Dis 2008; 197 Suppl 3: S279-93. (Review of the complications, natural history and management of hepatitis B in patients with HIV infection). 18447614
Nüesch R, Ananworanich J, Srasuebkul P, Chetchotisakd P, Prasithsirikul W, Klinbuayam W, Mahanontharit A, et al. Interruptions of tenofovir/emtricitabine-based antiretroviral therapy in patients with HIV/hepatitis B virus co-infection. AIDS 2008; 22: 152-4. (Among 10 patients with HIV-HBV coinfection on tenofovir therapy, 6 had a rise in HBV DNA levels and one had a clinically significant flare of hepatitis within 6 months of tenofovir withdrawal; all responded to restarting). 18090405
Sugiura K, Sugiura M, Takashi T, Naoki H, Itoh A. Immediate allergy, drug-induced eruption, by Entecavir. J Eur Acad Dermatol Venereol 2009; 23:487-9. (30 year old man with chronic hepatitis B developed a rash within 2 days of starting entecavir and had a positive skin test reaction; tolerated being switched to lamivudine without recurrence; role of entecavir uncertain as ALT was 3219 U/L on day it was started and had fallen to 921 U/L by 4 days). 18721215
Tenney DJ, Rose RE, Baldick CJ, Pokornowski KA, Eggers BJ, Fang J, Wichroski MJ, et al. Long-term monitoring shows hepatitis B virus resistance to entecavir in nucleoside-naïve patients is rare through 5 years of therapy. Hepatology 2009; 49: 1503-14. (Analysis of 663 patients from 6 trials of entecavir monitored for up to 5 years; antiviral resistance developed in only 1.2% of treatment-naïve, but 51% of lamivudine-resistant patients; no information on clinical or ALT features). 19280622
Shouval D, Lai CL, Chang TT, Cheinquer H, Martin P, Carosi G, Han S, et al. Relapse of hepatitis B in HBeAg-negative chronic hepatitis B patients who discontinued successful entecavir treatment: the case for continuous antiviral therapy. J Hepatol 2009; 50: 289-95. (In a trial in 275 entecavir- vs 245 lamivudine-treated patients, 1 patient developed entecavir resistance, but no accompanying clinical information; mild on-treatment ALT flares occurred in 3 [2%] and more marked withdrawal flares in 24 [8%] of entecavir-treated patients, usually with rise in HBV DNA levels and none being clinically apparent or associated with jaundice). 19070393
Fontana RJ. Side effects of long-term oral antiviral therapy for hepatitis B. Hepatology 2009; 49 (5 Suppl): S185-95. (Review of side effects of nucleoside analogues used to treat chronic hepatitis B). 19399802
Cohen SM, Levy RM, Jovanovich JF, Ahn J. Fatal lactic acidosis associated with the use of combination oral medications to treat reactivation of hepatitis B. J Clin Gastroenterol 2009; 43: 1008-10. (54 year old man with leukemia developed severe hepatitis B after a 4th monthly cycle of chemotherapy [ALT 2853 U/L, Alk P 112 U/L, bilirubin 20.9 mg/dL, INR 1.8] developed fatal lactic acidosis [pH 6.95, INR 4.4], with progressive liver failure 10 days later having started entecavir, adefovir and prednisone). 19461528
Lange CM, Bojunga J, Hofmann WP, Wunder K, Mihm U, Zeuzem S, Sarrazin C. Severe lactic acidosis during treatment of chronic hepatitis B with entecavir in patients with impaired liver function. Hepatology 2009; 50: 2001-6. (Among 16 patients with chronic hepatitis B and severe liver dysfunction started on entecavir, 5 developed evidence of lactic acidosis 4-240 days after starting, occurring only in those with severe dysfunction and accompanied by acidosis in 3). 19937695
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, lamivudine [26th, 45 cases] was among the 40 most commonly implicated drugs). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, but none to agents used in the treatment of hepatitis B). 20949552
Ortu F, Weimer LE, Floridia M, Manconi PE. Raltegravir, tenofovir, and emtricitabine in an HIV-infected patient with HCV chronic hepatitis, NNRTI intolerance and protease inhibitors-induced severe liver toxicity. Eur J Med Res 2010; 15: 81-3. (43 year old woman with HIV/HCV coinfection who developed symptomatic elevations of serum enzymes on saquinavir, fosamprenavir and again on darunavir, was adequately maintained on tenofovir/emtricitabine and raltegravir). 20452889
Dore GJ, Soriano V, Rockstroh J, Kupfer B, Tedaldi E, Peters L, Neuhaus J, Puoti M, Klein MB, Mocroft A, Clotet B, Lundgren JD; SMART INSIGHT study group. Frequent hepatitis B virus rebound among HIV-hepatitis B virus-coinfected patients following antiretroviral therapy interruption. AIDS 2010; 24: 857-65. (Among 54 patients with HIV-HBV coinfection who were withdrawn from chronic antiretroviral therapy, 12 [22%] had a >3 log rebound in HBV DNA levels, including 7 of 17 [41%] who had been on tenofovir vs 3 of 27 [11%] on lamivudine; ALT flares were uncommon and no patient developed hepatic decompensation). 20216301
Petersen J, Ratziu V, Buti M, Janssen HL, Brown A, Lampertico P, Schollmeyer J, et al. Entecavir plus tenofovir combination as rescue therapy in pre-treated chronic hepatitis B patients: An international multicenter cohort study. J Hepatol 2012; 56: 520-6. (Among 57 patients with chronic hepatitis B and advanced liver disease who had only a partial response to other antiviral agents, the combination of entecavir and tenofovir led to improvement in most patients and none developed lactic acidosis). 22037226
Perrillo R, Buti M, Durand F, Charlton M, Gadano A, Cantisani G, Loong CC, et al. Entecavir and HBIg in patients receiving liver transplant for chronic hepatitis B. Liver Transpl 2013; 19: 887-95. (Among 65 patients with chronic hepatitis B undergoing liver transplantation who received entecavir with or without HBIG, ALT flares occured in 6 patients [9%], all within 2 weeks of transplant and not associated with an increase in HBV DNA; by 72 weeks after transplant, HBsAg returned in 2 patients [3%], both without detectable HBV DNA). 23788462
Yu W, Zhao C, Shen C, Wang Y, Lu H, Fan J. The efficacy and safety of nucleos(t)ide analogues in patients with spontaneous acute exacerbation of chronic hepatitis B: a systematic review and meta-analysis. PLoS One 2013; 8: e65952. (Systematic review identified 15 studies of therapy of spontaneous acute exacerbations of chronic hepatitis; lamivudine and entecavir therapy were "relatively safe and well tolerated", but had no impact on short term mortality). 23776577
Yu S, Jianqin H, Wei W, Jianrong H, Yida Y, Jifang S, Liang Y, et al. The efficacy and safety of nucleos(t)ide analogues in the treatment of HBV-related acute-on-chronic liver failure: a meta-analysis. Ann Hepatol 2013; 12: 364-72. (Systematic review identified 5 studies of therapy of HBV related acute-on-chronic liver failure; lamivudine and entecavir therapy were associated with reduction in short term mortality). 23619252
Lok AS, Trinh H, Carosi G, Akarca US, Gadano A, Habersetzer F, Sievert W, et al. Efficacy of entecavir with or without tenofovir disoproxil fumarate for nucleos(t)ide-naïve patients with chronic hepatitis B. Gastroenterology 2012; 143: 619-28. (Among 379 patients with chronic hepatitis B treated with entecavir alone or entecavir with tenofovir for 2 years, 3 had ALT flares [>10 times ULN and twice baseline] on therapy, all with associated with a decrease in HBV DNA levels and subsequent loss of HBeAg, and none of 50 patients who were withdrawn from therapy had an ALT flare). 22643350
Manns MP, Akarca US, Chang TT, Sievert W, Yoon SK, Tsai N, Min A, Pangerl A, et al. Long-term safety and tolerability of entecavir in patients with chronic hepatitis B in the rollover study ETV-901. Expert Opin Drug Saf 2012; 11: 361-8. (Among 1051 patients with chronic hepatitis B treated with entecavir in a long term extension of previous controlled trials, 32 [3%] had an on-treament ALT flare [>10 times ULN and twice baseline], usually in association with a decrease in HBV DNA levels; 2 patients developed virologic breakthough and had an ALT flare when entecavir was stopped). 22233350
Hou JL, Jia JD, Wei L, Zhao W, Wang YM, Cheng M, Tang X, et al. Efficacy and safety of entecavir treatment in a heterogeneous CHB population from a ‘real-world’ clinical practice setting in China. J Viral Hepat 2013; 20: 811-20. (Among 2600 real world Chinese patients with chronic hepatitis B treated with entecavir for at least one year, 2 had ALT flares on treatment, both within 2 months of starting and resolving without complications, another patient developed an acute relapse after stopping therapy and another had a serious ALT elevation; few details given). 23876210
Luo J, Li X, Wu Y, Lin G, Pang Y, Zhang X, Ao Y, et al. Efficacy of entecavir treatment for up to 5 years in nucleos(t)ide-naïve chronic hepatitis B patients in real life. Int J Med Sci 2013; 10: 427-33. (Among 230 real life Chinese patients with chronic hepatitis B treated with entecavir for up to 5 years, none had a serious adverse event; no information provided on ALT flares of hepatotoxicity). 23471472
Wang X, Zhang C, Zhu Y, Xiong Y, Wang Y. Efficacy of 2 years of entecavir plus adefovir therapy in patients with chronic hepatitis B who had failed on prior nucleos(t)ide analog treatment. Antiviral Res 2014; 103: 71-7. (Among 104 previously treated patients with chronic hepatitis B given the combination of entecavir and adefovir for at least 2 years, none developed worsening liver disease, liver decompensation of hepatocellular carcinoma). 24462954
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none were attributed to agents used to treat hepatitis B). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but none to entecavir or other drugs used to treat hepatitis B). 25754159
Ahn J, Lee HM, Lim JK, Pan CQ, Nguyen MH, Ray Kim W, Mannalithara A, et al. Entecavir safety and effectiveness in a national cohort of treatment-naïve chronic hepatitis B patients in the US - the ENUMERATE study. Aliment Pharmacol Ther 2016; 43: 134-44. (In a multicenter observational study of 841 patients with chronic hepatitis B treated in clinical practice, response rates were similar to those in controlled trials and serious adverse events were largely judged to be unrelated, although 8 patients discontinued treatment because of an adverse event including 2 cases of non-fatal lactic acidosis that resolved without therapy; other adverse events included rash, arthralgia, abdominal discomfort, fatigue and alopecia). 26510638
Jonas MM, Chang MH, Sokal E, Schwarz KB, Kelly D, Kim KM, Ling SC, et al. Randomized, controlled trial of entecavir versus placebo in children with hepatitis B envelope antigen-positive chronic hepatitis B. Hepatology 2016; 63: 377-87. (Among 180 children or adolescents with chronic HBeAg-positive hepatitis B treated with entecavir or placebo for 48 weeks, loss of HBeAg was more frequent with entecavir [24% vs 11%], while ALT elevations above 5 times ULN were less frequent [2% vs 12%] and both instances on entecavir occurred in conjunction with loss of HBeAg). 26223345
Lee KS, Kweon YO, Um SH, Kim BH, Lim YS, Paik SW, Heo J, et al. Efficacy and safety of entecavir versus lamivudine over 5 years of treatment: A randomized controlled trial in Korean patients with hepatitis B e antigen-negative chronic hepatitis B. Clin Mol Hepatol 2017; 23: 331-9. (Among 120 Korean patients with chronic HBeAg-negative hepatitis B treated with entecavir or lamivudine for up to 5 years, virological responses were greater with entecavir and ALT elevations above 5 times ULN occurred in 10% of those on lamivudine, but in none of those on entecavir). 28946736
Kayaaslan B, Guner R. Adverse effects of oral antiviral therapy in chronic hepatitis B. World J Hepatol 2017; 9: 227-41. (Review of the safety and adverse effects of oral antiviral nucleoside analogues [including entecavir], mentions that the product labels all have a boxed warning regarding lactic acidosis and hepatic failure, although this has not been convincingly documented to occur with the nucleoside analogues approved as therapy of hepatitis B). 28261380
Kim CW, Kim CS, Kim HY, Lee CD, Yu K, Llamoso C, Lee HJ. Large-scale surveillance study of the safety and effectiveness of entecavir in Korean patients with chronic hepatitis B. Korean J Intern Med 2018; 33: 91-101. (Among 3366 Koreans with chronic hepatitis B treated with entecavir in routine clinical practice between 2006 and 2012, the reported adverse event rate was 7.6% and serious adverse event rate 0.3% [9 patients], all of which were considered unrelated to entecavir and there were no instances of hypersensitivity reactions, anaphylaxis or acute liver injury). 29228519

## OTHER REFERENCE LINKS

1. Recent References on Entecavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Entecavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Entecavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Entecavir)